# Ibrexafungerp

## OVERVIEW

### Introduction

Ibrexafungerp is a triterpenoid antifungal agent used to treat as well as prevent recurrent episodes of vulvovaginal candidiasis. Ibrexafungerp therapy has not been associated with elevations in serum enzyme elevations or with instances of jaundice or clinically apparent liver injury.

### Background

Ibrexafungerp (eye brex” a funj’ erp) is a triterpenoid antifungal agent used to treat acute vulvovaginal candidiasis well as prevent episodes of recurrent vulvovaginitis. Its mechanism of action is believed to be due to inhibition of β-1,3-D glucan synthetase, which weakens fungal cell wall formation and integrity causing fungal cell death. Ibrexafungerp inhibits growth of multiple candida species in cell culture and was found effective in treating candidiasis in animal models. In randomized controlled trials, ibrexafungerp led to clinical cures of acute candidal vulvovaginitis within two weeks in at least 50% of women and adolescent post-menarchal girls. Ibrexafungerp was approved as therapy for vulvovaginal candidiasis in post-menarchal females in the United States in 2021 and is available under the brand name of Brexafemme in tablets of 150 mg. The recommended dose for treatment of acute vulvovaginal candidiasis is 300 mg (two tablets) twice in one day, approximately 12 hours apart. Indications were expanded in 2022 to include prevention of recurrent vulvovaginal candidacies. The dose for prevention is the same regimen as for acute but given once a month for 6 months. Therapy is generally well tolerated, but side effects can include mild-to-moderate degrees of diarrhea, nausea, vomiting, abdominal discomfort, dizziness, headache, and fatigue. Ibrexafungerp causes fetal abnormalities in animals and has a boxed warning against its use during pregnancy. Females of child-bearing potential should be tested for pregnancy before starting ibrexafungerp and practice an effective means of contraception during therapy and for at least 4 days after the last dose.

### Hepatotoxicity

In registration trials, liver test abnormalities occurred in less than 1% of patients treated with ibrexafungerp for acute vulvovaginal candidiasis. The elevations were transient and not associated with symptoms or jaundice and not significantly more common than with placebo (0.7% vs 0.4%). However, in phase 1 studies in healthy volunteers, 2 subjects developed marked ALT elevations within 11 days of a single dose accompanied by mild symptoms. The abnormalities resolved but remained unexplained. Liver test results during chronic administration of ibrexafungerp for prevention of recurrent vulvovaginal candidiasis have not been reported. Since its approval, there have been no reports of clinically apparent liver injury due to ibrexafungerp, but it has had only limited clinical use, and the treatment regimen for acute vulvovaginitis is for one day only.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which ibrexafungerp might cause liver injury is not known. Humans do not have glucan synthetase, so the enzyme inhibition is unlikely to be harmful. On the other hand, ibrexafungerp is a large, complex molecule and is metabolized in the liver by the cytochrome P450 system, predominantly CYP 3A4, which may generate toxic intermediates. Also, because it is a substrate of CYP 3A4, it is susceptible to drug-drug interactions with agents that inhibit or induce this microsomal enzyme, and the dose should be reduced to 150 mg given twice in one day for patients taking a moderate or strong CYP 3A4 inhibitor. Finally, the gastrointestinal symptoms related to ibrexafungerp may be due to alterations in the microbiome which could possibly have secondary effects.

### Outcome and Management

Ibrexafungerp has not been linked to severe elevations in serum aminotransferase levels during therapy or to episodes of clinically apparent acute liver injury. Monitoring of liver tests is not recommended for women receiving ibrexafungerp either acutely for treatment or chronically for prevention of vulvovaginal candidiasis. The appearance of signs or symptoms of liver injury during or shortly after such therapy should lead to a search for the cause of the abnormalities, and temporary discontinuation until the cause is identified.

Drug Class: Antifungal Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ibrexafungerp – Brexafemme®

DRUG CLASS

Antifungal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ibrexafungerp)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ibrexafungerp | 1207753-03-4 | C44-H67-N5-O4

## ANNOTATED BIBLIOGRAPHY

References updated: 25 January 2025

Zimmerman HJ. Antifungal agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 609-11. (Expert review of hepatotoxicity of antifungal agents published in 1999 before the availability of ibrexafungerp).
Moseley RH. Antifungal agents. Antibacterial and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 470-3. (Review of hepatotoxicity of antifungal agents before the availability of ibrexafungerp or other inhibitors of β-1,3,-D glucan).
Rogers PD, Krysan DJ. Antifungal agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1987-1104. (Textbook of pharmacology and therapeutics discusses the echinocandins (-fungins) which inhibit β-1,3-D glucan synthesis, but not ibrexafungerp).
FDA. Multi-Discipline Review. 2021. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/214900Orig1s000MultidisciplineR.pdf (FDA website with product label and multidiscipline review of ibrexafungerp based upon data submitted by the sponsor in support of its approval for use in vulvovaginal candidiasis, mentions that 2 healthy subjects in phase 1 trials of a single dose of ibrexafungerp developed ALT elevations [peak 575 and 275 U/L] with mild symptoms, that resolved spontaneously, and that the rate of ALT elevations in phase 3 trials of therapy of acute vulvovaginal candidiasis was 0.7% [4/575] on ibrexafungerp vs 0.4% [1/275] on placebo, and none of the elevations was associated with symptoms or jaundice).
Lee A. Ibrexafungerp: first approval. Drugs. 2021;81:1445-1450. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of ibrexafungerp shortly after its approval for use in the US, mentions common adverse events of diarrhea [17%], nausea [12%], abdominal pain [11%], dizziness [3%], and vomiting [2%] and the lack of serious adverse events in registration trials; no mention of ALT elevations or hepatotoxicity). 34313977
Ibrexafungerp (Brexafemme) for vulvovaginal candidiasis. Med Lett Drugs Ther. 2021;63:141-143. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of ibrexafungerp mentions the common adverse events of diarrhea, nausea and vomiting, abdominal pain, and dizziness, but does not mention ALT elevations or hepatotoxicity). 34550113
Sobel R, Nyirjesy P, Ghannoum MA, Delchev DA, Azie NE, Angulo D, Harriott IA, et al. Efficacy and safety of oral ibrexafungerp for the treatment of acute vulvovaginal candidiasis: a global phase 3, randomised, placebo-controlled superiority study (VANISH 306). BJOG. 2022;129:412-420. (Among 272 women with acute vulvovaginitis treated with a one day course of ibrexafungerp [300 mg twice] or placebo, clinical cure was more frequent with drug [63% vs 44%], as was mycological eradication and improvement in symptoms, and while adverse events were more frequent with ibrexafungerp [15% vs 4%], side effects were mostly mild-to-moderate nausea or diarrhea, and there were no serious adverse events; no mention of ALT elevations or hepatotoxicity). 34676663
Schwebke JR, Sobel R, Gersten JK, Sussman SA, Lederman SN, Jacobs MA, Chappell BT, et al. Ibrexafungerp versus placebo for vulvovaginal candidiasis treatment: a phase 3, randomized, controlled superiority trial (VANISH 303). Clin Infect Dis. 2022;74:1979-1985. (Among 371 women with vulvovaginal candidiasis treated with a one day course of ibrexafungerp [300 mg twice] or placebo, clinical cure rates were higher with drug [51% vs 29%], as were rates of mycological eradication and improvement in symptoms, while adverse event rates were higher with ibrexafungerp [40% vs 17%] being largely nausea and diarrhea; no mention of ALT elevations or hepatotoxicity). 34467969
Nyirjesy P, Schwebke JR, Angulo DA, Harriott IA, Azie NE, Sobel JD. Phase 2 randomized Study of oral ibrexafungerp versus fluconazole in vulvovaginal candidiasis. Clin Infect Dis. 2022;74:2129-2135. (Among 186 patients with vulvovaginal candidiasis treated with 6 different 1- or 2-day regimens of ibrexafungerp vs fluconazole, efficacy and safety results were reported for the 62 who received the recommended regimen of each agent, the clinical cure rate at 10 days was 52% vs 58% and adverse event rate 47% vs 25%; no mention of ALT elevations or hepatotoxicity). 34555149
Goje O, Sobel R, Nyirjesy P, Goldstein SR, Spitzer M, Faught B, Larson S, et al. Oral ibrexafungerp for vulvovaginal candidiasis treatment: an analysis of VANISH 303 and VANISH 306. J Womens Health (Larchmt). 2023;32:178-186. (Summary of combined results of two clinical trials of ibrexafungerp [Sobel 2022; Schwebke 2022] for acute vulvovaginal candidiasis, mentions that safety results were similar to those reported in the trials and that mild-to-moderate gastrointestinal complaints were the most common adverse events). 36255448

## OTHER REFERENCE LINKS

1. Recent References on Ibrexafungerp: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ibrexafungerp/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on ibrexafungerp: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ibrexafungerp)